# Eprosartan

## OVERVIEW

### Introduction

Eprosartan is an angiotensin II receptor blocker used in the therapy of hypertension. Eprosartan is associated with a low rate of transient serum aminotransferase elevations but has yet to be linked to instances of acute liver injury.

### Background

Eprosartan (ep" roe sar' tan) is an angiotensin II receptor blocker (ARB) used alone or in combination with other agents for therapy of hypertension. Eprosartan inhibits the renin-angiotensin system by blocking the angiotensin II type 1 receptor (AT1), which prevents the vasoconstriction and volume expansion induced by circulating angiotensin II thus accounting for its antihypertensive activity. Eprosartan was approved for use in the United States in 1997 for the treatment of hypertension. Eprosartan is available in 400 and 600 mg tablets generically and under the trade name Teveten. The typical dose in adults in 400 to 800 mg daily in one or two divided doses, and it is used long term. Eprosartan is also available in fixed combinations with hydrochlorothiazide (Teveten HCT). Side effects are uncommon, but can include headache, dizziness, fatigue, edema, cough, gastrointestinal upset, and fetal toxicity. Many ARBs including eprosartan have been linked to rare instances of a severe sprue-like enteropathy that presents with chronic diarrhea and weight loss and villous flattening and atrophy on intestinal biopsy. The diarrhea usually arises after 6 months or more of therapy and does not respond to corticosteroids or a gluten-free diet, but does resolve promptly with stopping eprosartan. This adverse side effect is most common wtih olmesartan.

### Hepatotoxicity

Eprosartan has been associated with a low rate of serum aminotransferase elevations (<2%) that in controlled trials was no higher than with placebo therapy. These elevations were transient and rarely required dose modification. No specific instances of clinically apparent acute liver injury have been reported in association with eprosartan therapy, but like other ARBs, it may be associated with rare instances of symptomatic hepatotoxicity. The typical onset of ARB-associated liver injury is within 1 to 8 weeks of starting therapy and the serum enzyme pattern is typically hepatocellular with an acute hepatitis-like clinical syndrome. In some instances, cholestasis has developed which can be prolonged and relapsing, but ARB therapy has not been associated with vanishing bile duct syndrome or chronic liver injury. Immunoallergic manifestations (rash, fever, eosinophilia) are not common, nor is autoantibody formation. In addition, some patients with ARB-related enteropathy also develop fatty liver and steatohepatitis which can be associated with serum aminotransferase elevations.

Likelihood score: E* (Unproved but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the minor serum aminotransferase elevations with eprosartan is not known. Eprosartan is metabolized in the liver to a glucuronide which is excreted in the urine. Eprosartan does not appear to be metabolized by the cytochrome P450 system and has minimal drug-drug interactions.

### Outcome and Management

The instances of acute liver injury reported with ARB use have been self limited and have not resulted in acute liver failure or chronic liver injury. While corticosteroids have been used in cases of severe cholestasis due to ARBs, their efficacy has not been shown and their use is best avoided. Patients with eprosartan induced liver injury should probably avoid use of other ARBs, although cross sensitivity to liver injury among the members of this class of agents has not been shown.

References on the safety and potential hepatotoxicity of eprosartan are given in the Overview section on the angiotensin II receptor antagonists.

Drug Class: Antihypertensive Agents, Angiotensin II Receptor Antagonists

Other Drugs in the Subclass, Angiotensin II Receptor Antagonists: Azilsartan, Candesartan, Irbesartan, Losartan, Olmesartan, Telmisartan, Valsartan

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Eprosartan – Teveten®

DRUG CLASS

Angiotensin II Receptor Antagonists

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Eprosartan)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Eprosartan | 133040-01-4 | C23-H24-N2-O4-S | Chemical Structure for Eprosartan

## OTHER REFERENCE LINKS

1. Recent References on Eprosartan: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Eprosartan+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Eprosartan: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Eprosartan)